# Ketoconazole

## OVERVIEW

### Introduction

Ketoconazole is an imidazole fungicidal agent with a very broad spectrum of activity against many fungal species that is used for treatment of superficial and systemic fungal infections. Ketoconazole is a well documented cause of clinically apparent acute drug induced liver injury and is no longer recommended as a first line antifungal agent.

### Background

Ketoconazole (kee" toe kon' a zole) is an imidazole derivative and fungicidal agent which is believed to work by several mechanisms, including inhibition of the fungal 14α-ergosterol demethylase which is responsible for converting lanosterol to ergosterol and which blocks fungal cell membrane synthesis. Ketoconazole may also inhibit fungal triglyceride and phospholipid synthesis and fungal oxidative and peroxidative enzyme activity, causing accumulation of hydrogen peroxide, contributing to deterioration of organelles. Ketoconazole has been used in the treatment of many fungal infections including blastomycosis, candidiasis, coccidiomycosis, tinea pityriasis versicolor and histoplasmosis. Ketaconazole has also been used as adjuvant therapy of prostate cancer, because of its effects in lowering androgen production by both the testes and adrenal glands. Ketoconazole was approved for use in the United States in 1981, but has been replaced by other antifungal agents which have fewer side effects and wider range of activity. Because of its potential for severe adverse reactions including hepatotoxicity, ketoconazole has been withdrawn in many countries and has strict labeling in the United States recommending that it be used only when other effective antifungal agents are not available or tolerated. Current indications include systemic fungal infections due to candida, blastomycosis, coccidiomycosis, histoplasmosis, chromomycosis and paracoccidioidomycosis. Ketoconazole is available as 200 mg tablets in several generic forms and previously under the brand name of Nizoral. The recommended dose for fungal infections is 200 to 400 mg once daily by mouth in adults and 3.3 to 6.6 mg/kg in children older than 2 years of age. The dose used for prostate cancer is 400 mg three times daily. Ketoconazole is also available as a cream, solution and shampoo for cutaneous fungal infections. Common side effects include pruritus, nausea, rash, abdominal pain, headache, dizziness, fatigue, impotence, menstrual abnormalities and gynecomastia. Severe adverse events include anaphylaxis, hepatotoxicity, endocrine dysregulation and prolongation of the QTc interval.

### Hepatotoxicity

Mild and transient elevations in liver enzymes occur in 4% to 20% of patients on oral ketaconazole. These abnormalities are usually transient and asymptomatic and uncommonly require dose adjustment or discontinuation. Clinically apparent hepatotoxicity from ketaconazole is well described in the literature and is estimated to occur in 1:2,000 to 1:15,000 users. The liver injury typically presents with an acute hepatitis-like picture 1 to 6 months after starting therapy. While most cases present with a hepatocellular pattern of injury, cholestatic forms have been described. Rash, fever and eosinophilia are rare as is autoantibody formation. Recovery upon stopping therapy may be delayed and generally takes 1 to 3 months. Severe cases with acute liver failure and death or need for emergency liver transplantation have been described.

Likelihood score: A (well established cause cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of clinically apparent hepatotoxicity from ketoconazole is unknown; however, it may correlate with the ability of ketoconazole to inhibit mammalian sterol synthesis. Acute liver injury is clearly idiosyncratic. Ketoconazole is a potent inhibitor of human CYP 3A4 and can alter the serum levels of many drugs that are metabolized via the P450 system, increasing the toxicity of these agents. Indeed, it is often used to assess the effects of CYP 3A4 inhibition on the metabolism of other drugs.

### Outcome and Management

The severity of the liver injury from ketoconazole ranges from mild and transient enzyme elevations (Case 1) to symptomatic acute liver injury with jaundice (Case 2), to severe hepatitis and acute liver failure (Case 4), resulting in death or need for emergency liver transplantation. Recovery from ketoconazole hepatitis is typically slow, starting 1 to 4 weeks after stopping the medication and requiring 1 to 3 months for full recovery. At least one case of chronic hepatitis and cirrhosis has been linked to ketoconazole therapy (Case 3). Rechallenge leads to recurrence and should be avoided. There is little information on cross reactivity of hepatic injury between ketoconazole and other antifungal azoles, such as itraconazole, fluconazole, voriconazole and posaconazole, but a few reports suggest that there is little cross reactivity. Nevertheless, other azoles should be started with caution in patients who have suffered clinically apparent hepatotoxicity attributed to ketoconazole.

Drug Class: Antifungal Agents

## CASE REPORTS

### Case 1. Acute self-limited serum enzyme elevations during ketoconazole therapy.

[Modified from: Leal-Cerro A, García-Luna PP, Jiménez Mejías E, Astorga R. [Hepatotoxicity of ketoconazole in patients with adrenal pathology]. Med Clin (Barc) 1987; 88: 519. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/3586729)]

A woman was started on ketoconazole as experimental therapy of Cushings syndrome and had regular blood test monitoring for liver injury at weekly intervals (Table). Serum ALT levels became abnormal after 14 days and peaked at 21 days, with minimal increase in serum alkaline phosphatase and no increase in serum bilirubin or appearance of symptoms. ALT levels fell to normal by week 5 despite continuation of ketoconazole at the same dose.

#### Key Points

Medication: | Ketoconazole (daily)
Pattern: | Hepatocellular (R=7.0)
Severity: | 1+ (serum enzyme elevations without jaundice)
Latency: | 14 days
Recovery: | 3 weeks
Other medications: | None mentioned

#### Laboratory Values

Weeks After Starting | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL)
0 | 37 | 26 | 145 | 0.2
1 | 30 | 19 | 162 | 0.3
2 | 353 | 166 | 260 | 0.3
3 | 79 | 38 | 252 | 0.4
4 | 34 | 33 | 212 | 0.3
5 | 36 | 33 | 215 | 0.3
Normal Values | <50 | <50 | <279 | <1.2

#### Comment

A typical example of mild-to-moderate serum aminotransferase elevations during the first few weeks of ketaconazole therapy with spontaneous resolution despite continuing therapy without dose modification. The phenomenon is referred to as "adaptation" and its mechanism is unknown.

### Case 2. Ketoconazole induced acute, self-limited hepatitis.

[Modified from: Svejgaard E, Ranek L. Hepatic dysfunction and ketoconazole therapy. Ann Intern Med 1982; 96 (6 Pt 1): 788-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/6283980)]

A 48 year old man developed nausea and fatigue 81 days after starting ketoconazole (200 mg daily) for fingernail onychomycosis. Serum ALT levels were normal before therapy and had been only minimally elevated at 8 weeks. On presentation, he was jaundiced but without fever or rash. Serum bilirubin was 6.3 mg/dL and serum aminotransferase levels were markedly elevated. Tests for hepatitis A and B were negative and ultrasound and CT scans of the abdomen showed no evidence of biliary obstruction or chronic liver disease. The patient remained jaundiced for a month, but serum enzymes then began to fall and were normal 2 months later (Table).

#### Key Points

Medication: | Ketoconazole (200 mg daily)
Pattern: | Hepatocellular (R=12.8)
Severity: | 3+ (jaundice leading to hospitalization)
Latency: | 3 months
Recovery: | 2 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 13 | | | Before ketoconazole
3 months | 0 | 1030 | | | One more dose given
| 1 day | 1900 | 450 | 6.2 | Ultrasound normal
3.5 months | 2 weeks | 1450 | 480 | 6.5
4 months | 4 weeks | 480 | 240 | 3.0
5 months | 8 weeks | 31 | 158 | 0.8
Normal Values | | <40 | <275 | <1.2

#### Comment

A typical case of hepatocellular injury due to ketoconazole arising after 3 months of therapy, despite monitoring for liver injury with monthly blood tests as a part of a clinical trial of this azole for superficial onychomycosis. Recovery was spontaneous but was slightly delayed as is typical of ketoconazole hepatotoxicity.

### Case 3. Ketoconazole induced liver cirrhosis.

[Modified from: Kim TH, Kim BH, Kim YW, Yang DM, Han YS, Dong SH, Kim HJ, et al. Liver cirrhosis developed after ketoconazole-induced acute hepatic injury. J Gastroenterol Hepatol 2003; 18: 1426-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/14675275)]

A 41 year old woman developed nausea, vomiting, anorexia, and jaundice after taking ketoconazole (200 mg daily) for 4.5 months for onychomycosis. Before starting therapy, serum aminotransferase and bilirubin levels were normal. On presentation, she had jaundice but no fever or rash. Serum bilirubin was 12.8 mg/dL and ALT 1461 U/L. Tests for viral hepatitis A, B, C and E were negative as were autoantibodies including ANA and AMA. Over the next four months bilirubin levels remained high and serum albumin fell. Ascites was found after 4 months and upper endoscopy showed varices. Liver biopsy showed cirrhosis; bile duct damage was not mentioned. During long term follow up, liver tests improved, but remained abnormal even five years after the acute injury and discontinuation of ketoconazole.

#### Key Points

Medication: | Ketoconazole (200 mg daily)
Pattern: | Hepatocellular (R=16)
Severity: | 4+ (prolonged jaundice and cirrhosis)
Latency: | 4.5 months
Recovery: | Incomplete
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
Pre | | 23
5 months | 0 | 1461 | 268 | 12.3 | Symptomatic onset
| 1 week | 1800 | | 24.0 | INR 1.2
6 months | 4 weeks | 205 | | 31.0 | Albumin 2.4
| 6 weekls | 170 | | 30.0
7 months | 8 weeks | 180 | | 30.4
| 11 weeks | 120 | | 22.8
8 months | 13 weeks | 150 | | 12.9
| 15 weeks | 110 | | 9.9
9 months | 4 months | 80 | | 7.6 | Ascites, varices
12 months | 6 months | 60 | | 2.9 | Liver biopsy: cirrhosis
14 months | 9 months | 50 | | 1.2 | Albumin 3.3
Normal Values | | <35 | <117 | <1.2

*Some values estimated from Figure 2.

#### Comment

An unusual case of drug induced liver injury. The initial presentation with acute, severe hepatocellular jaundice arising 5 months after starting ketoconazole in a middle aged woman was typical of this form of drug induced liver injury. However, the evidence of liver injury persisted and four months later clinical evidence of cirrhosis was present. Laboratory values remained abnormal even five years after the initial presentation and discontinuation of ketoconazole. The liver biopsy showed cirrhosis, but the report does not mention evidence of biliary damage as might be seen in vanishing bile duct syndrome or primary biliary cirrhosis or sclerosing cholangitis. Most drugs that have been implicated in causing cirrhosis are given for prolonged periods (minocycline, methyldopa, amiodarone, valproate) and induction of chronic hepatitis by an limited course of therapy is usually accompanied by features of autoimmunity such as antinuclear antibody. Alternatively, the clinical syndrome may represent “post-hepatitic” inactive cirrhosis due to the severity of the acute hepatitis and that is not associated with progressive liver injury.

### Case 4. Acute liver failure due to ketoconazole.

[Modified from: Knight T, Shikuma C, Knight J. Ketoconazole-induced fulminant hepatitis necessitating liver transplantation. J Am Acad Dermatol 1991; 25: 398-400. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/1832694)]

A 45 year old woman treated with ketoconazole for candidal onychomycosis developed anorexia, nausea, malaise, and dark-colored urine after 58 days of therapy. She discontinued the medication promptly. Physical examination revealed hepatic tenderness and mild jaundice but no fever or rash. Blood tests showed bilirubin of 4.2 mg/dL, alkaline phosphatase 102 U/L, and AST 1328 U/L. During the second week of illness, she developed worsening symptoms and jaundice that progressed to liver failure and hepatic coma that prompted emergency liver transplantation.

#### Key Points

Medication: | Ketoconazole (200 mg daily)
Pattern: | Hepatocellular (R=79)
Severity: | 5+ (jaundice, hepatic failure, liver transplantation)
Latency: | 58 days
Recovery: | None
Other medications: | Levothyroxine

#### Comment

A example of ketaconazole hepatotoxicity, presenting after two months of therapy with an acute hepatitis-like syndrome, but then progressing to acute liver failure. Improvement upon stopping therapy can be delayed with progressive worsening over the 1 to 4 weeks after discontinuation of treatment. Minor allergic signs and symptoms (rash and eosinophilia) may be present early in the course, but are rarely severe. Corticosteroid therapy has been applied to patients with ketaconazole hepatotoxicity, but its efficacy in ameliorating the course of illness has not been shown.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ketoconazole – Generic, Nizoral®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ketoconazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ketoconazole | 65277-42-1 | C26-H28-Cl2-N4-O4 | Image of Ketoconazole Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 17 May 2017

Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999; mentions that ketoconazole has been implicated in many cases of liver injury, more often in woman, usually hepatocellular arising after 1-24 weeks, occasionally fatal).
Moseley RH. Antifungal agents. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-3. (Review of hepatotoxicity of antifungal agents mentions that symptomatic liver injury occurs in 1:2000 to 1:10,000 persons taking ketaconazole and up to 17.5% of treated patients have asymptomatic aminotransferase elevations).
Bennett JE. Antifungal agents. In, Brunton LL, Chabner B, Knollman K, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1571-91. (Textbook of pharmacology and therapeutics; ketoconazole has been replaced in large part by itraconazole, which lacks the corticosteroid suppressive activity of ketoconazole and has an expanded antifungal spectrum).
Petersen EA, Alling DW, Kirkpatrick CH. Treatment of chronic mucocutaneous candidiasis with ketoconazole. Ann Intern Med 1980; 93: 791-5. (Controlled trial of 6 month course of ketoconazole vs placebo in 12 patients with chronic mucocutaneous candidiasis with subsequent cross-over; marked beneficial effect in all treated patients; one developed ALT and Alk P elevations without jaundice that improved with lowering dose). 6255844
Heiberg JK, Svejgaard E. Toxic hepatitis during ketoconazole treatment. Br Med J (Clin Res Ed) 1981; 283: 825-6. (68 year old woman developed pruritus after 14 weeks of ketoconazole followed by dark urine with ALT ~275 U/L, resolving rapidly and recurring with reexposure; biopsy with portal inflammation; three liver biopsies). 6271328
Macnair AL, Gascoigne E, Heap J, Schuermans V, Symoens J. Hepatitis and ketoconazole therapy. Br Med J (Clin Res Ed) 1981; 283: 1058-9. (Summary of monitoring of liver tests in study of 988 patients from Janssen Pharmacuticals finding little evidence of hepatic injury; 3 reported cases of hepatitis during therapy, all resolved with stopping therapy). 6271330
Firebrace DAJ. Hepatitis and ketoconazole therapy. Br Med J (Clin Res Ed) 1981; 283; 1058-9. (62 year old man developed jaundice 2 months after starting ketaconazole [bilirubin 2.8 mg/dL, ALT 697 U/L, Alk P 396 UL], resolving despite continuing therapy). 6271330
Adams JG. Jaundice and other drug reactions to ketoconazole. Australas J Dermatol 1982; 23: 90. (31 cases of jaundice or symptomatic hepatitis related to ketaconazole therapy reported to Janssen Pharmaceuticals, onset between 3 and 24 weeks). 6295356
Horsburgh CR Jr, Kirkpatrick CH, Teutsch CB. Ketoconazole and the liver. Lancet 1982; 1: 860. (Letter stressing hepatic side effects of ketoconazole; transient enzyme elevations occurred in 4 of 12 patients and 1 developed clinically apparent hepatitis in the study by Peterson et al. [1980]; since then, another patient had rise of AST to 1100 U/L, resolving with stopping). 6122089
Svejgaard E, Ranek L. Hepatic dysfunction and ketoconazole therapy. Ann Intern Med 1982; 96 (6 Pt 1): 788-9. (48 year old man developed fatigue and nausea 81 days after starting ketoconazole [bilirubin 6.3 mg/dL, AST 1030 U/L, Alk P 450 U/L], resolving 2 months after stopping: Case 2). 6283980
Strauss JS. Ketaconazole and the liver. J Am Acad Dermatol 1982; 6: 546-7. (52 year old woman developed intermittent AST elevations without jaundice during ketoconazole therapy; AST finally rising to 346 U/L at 7 months when it was stopped; ALT 575 U/L one week later, but fell to normal in next 8 weeks). 6281318
Tkach JR, Rinaldi MG. Severe hepatitis associated with ketoconazole therapy for chronic mucocutaneous candidiasis. Cutis 1982; 29: 482-4. (6 year old boy with chronic cutaneous candidiasis developed jaundice 5 months after starting ketaconazole [bilirubin 10.4 rising to 15.6 mg/dL and ALT 1980 U/L], with slow but complete resolution in 3 months). 6284445
van Dijke CP. [Hepatitis during the administration of ketoconazole (Nizoral)]. Ned Tijdschr Geneeskd 1983; 127: 339-41. (5 cases of liver injury: 3 women and 2 men, ages 24 to 54, with dermatomycosis developed abnormal liver tests 1 to 6 months after starting oral ketoconazole [bilirubin normal to 6.4 mg/dL, ALT 308 to 790 U/L, Alk P normal] resolving in few weeks to 3 months after stopping). 6300701
Boëtius G, Peeters JP, Peters JH. [Toxic hepatitis caused by ketoconazole (Nizoral)]. Ned Tijdschr Geneeskd 1983; 127: 341-3. Dutch. (2 cases of liver injury: two women, ages 54 and 49 developed dark urine 3 and 4 months after starting ketoconazole [bilirubin 5.6 and 29.2 mg/dL, ALT 85 and 1092 U/L, Alk P 262 and 189 U/L], resolving clinically within 6 and 8 weeks after stopping). 6300702
Kramer NJ, Montnor LP, Berghuis PH. [Toxic hepatitis during the administration of ketoconazole(Nizoral)]. Ned Tijdschr Geneeskd 1983; 127: 343-4. (24 year old woman developed nausea followed by jaundice 4 months after starting ketoconazole for dermatomycosis [bilirubin 6.4 mg/dL, ALT 785 U/L, Alk P 98 U/L], resolving within 6 weeks of stopping: patient D in van Dijke [1983]). 6300703
Bekkers GAH. [Toxic hepatitis due to ketoconazole]. Toxische hepatitis door ketoconazol. Ned Tijdschr Geneesk 1983; 127: 1114-5. Not in PubMed
Haneke E. [Side effects of ketoconazole]. Z Hautkr 1983; 58: 1542-7. 6318466
Boughton K. Ketoconazole and hepatic reactions. S Afr Med J 1983; 63: 955. (Among 1.3 million patients treated with ketoconazole worldwide, 96 reports of symptomatic liver damage were made to Janssen Pharmaceutics, for an estimated incidence of ~1:10,000, 3 deaths). 6304923
Henning H, Kasper B, Lüders CJ. [Ketoconazole-induced hepatitis. Case report]. Z Gastroenterol 1983; 21: 709-15. (62 year old woman developed fatigue 2 and jaundice 4 weeks after starting ketaconazole [bilirubin 7.6 mg/dL, ALT 1197 U/L, Alk P 524 U/L], resolving after 4-5 months, positive rechallenge to two doses [ALT rising to 176 U/L] and biopsy showing portal inflammation and focal necrosis). 6141674
Janssen PA, Symoens JE. Hepatic reactions during ketoconazole treatment. Am J Med 1983; 74: 80-5. (Summary of reports of symptomatic liver injury due to ketoconazole; 14% of 1074 patients had liver test abnormalities identified during routine monitoring, but many had elevations before therapy and none had symptoms, and elevations often resolved even with continuation of therapy; 31 reports of symptomatic hepatitis, 25 with jaundice, mean onset at 8 weeks [range 1-24], all resolved except one death from acute liver failure; two rechallenged and both had recurrence; estimated frequency 1:10,000 exposures). 6129799
Pegram S, Kerns FT, Wasilauskas BL, Hampton KD, Scharyj M, Bruke JG. Successful ketoconazole treatment of protothecosis with ketoconazole associated hepatotoxicity. Arch Intern Med 1983; 143: 1802-5. (46 year old woman with treatment resistant algae-like Prototheca wickerhamil wound infection responded to ketaconazole therapy, but she developed jaundice after 10 weeks [bilirubin 3.5 mg/dL, AST 873 U/L and Alk P 455 U/L], resolving with stopping therapy). 6311129
Okumura H, Aramaki T, Satomura K, Iizuka K, Ohta M, Katsuta Y, Akaike M, et al. Severe hepatitis during ketoconazole therapy. Gastroenterol Jpn 1983; 18: 142-7. (31 year old woman developed fatigue 3 months after starting ketoconazole [bilirubin 1.2 mg/dL, ALT 604 U/L, Alk P 102 U/L], but with worsening over the next 4 weeks, slowly resolving 3 months later). 6303886
Rollman O, Lööf L. Hepatic toxicity of ketoconazole. Br J Dermatol 1983; 108: 376-8. (4 of 36 patients had liver injury during ketaconazole therapy; most severe in a 37 year old man who developed pain after 6 months with ALT rising to 360 U/L, treated with prednisone; two asymptomatic cases with ALT elevations only, and one 43 year old man who developed jaundice and eosinophilia after 1 month of ketaconazole). 6299322
Duarte PA, Chow CC, Simmons F, Ruskin J. Fatal hepatitis associated with ketoconazole therapy. Arch Intern Med 1984; 144: 1069-70. (67 year old woman developed jaundice 2 months after starting ketoconazole [bilirubin 15 mg/dL, ALT 1580 U/L, Alk P 69 U/L], progressing to hepatic coma and death in 11 days: autopsy showed massive necrosis). 6324708
Lewis JH, Zimmerman HJ, Benson GD, Ishak KG. Hepatic injury associated with ketoconazole therapy. Analysis of 33 cases. Gastroenterology 1984; 86: 503-13. (Retrospective analysis of 33 cases of ketaconazole hepatotoxicity reported to FDA and Janssen: 11 men and 22 women; range in age of 5 to 93 years, latency averaged 56 days [range 10-219]; no hypersensitivity features; largely hepatocellular pattern of enzymes, but 15% cholestatic; 97% recovered in 1 to 16 weeks; no chronic hepatitis). 6319220
Pérez-Mateo M, Sillero C, Vázquez N. [Is ketoconazole hepatotoxic at high doses?]. Med Clin (Barc) 1984; 83: 780. (18 year old woman took overdose of ketoconazole [~6 g]; gastric lavage demonstratingly minimized residual pills; biochemical tests were normal over the next 24 hours and were normal in follow up weekly for one month; little evidence for direct toxicity of ketoconazole). 6097780
Roudot-Thoraval F, Dhumeaux D. [Hepatitis during treatment with ketoconazole]. Gastroenterol Clin Biol 1984; 8: 92. (25 year old woman developed abdominal pain and fatigue during 20 day course of ketoconazole that persisted for 4 weeks [bilirubin 1.0 mg/dL, ALT 190 U/L, Alk P 90 U/L], symptoms and laboratory abnormalities resolving over the next few weeks). 6321289
Savin RC. Systemic ketoconazole in tinea versicolor: a double-blind evaluation and 1-year follow-up. J Am Acad Dermatol 1984; 10 (5 Pt 1): 824-30. (Controlled trial of 4 weeks of ketoconazole vs placebo in 66 patients; significant increase in ALT without change in bilirubin in 1 ketoconazole treated patient). 6327784
Svedhem A. Toxic hepatitis following ketoconazole treatment. Scand J Infect Dis 1984; 16: 123-5. (61 year old woman developed rising ALT levels 4 months after starting ketoconazole [bilirubin normal but then rising to 16.4 mg/dL, ALT 1680 U/L, Alk P 540 U/L], resolving in 2 months). 6320358
Bercoff E, Bernau J, Degott C, Kalis B, Lemaire A, Tilly H, Rueff B, et al. Ketoconazole-induced fulminant hepatitis. Gut 1985; 26: 636-8. (2 cases of acute liver failure arising 17 and 103 days after starting ketoconazole with progression to ascites, coma and death during the month after stopping; autopsy showed massive necrosis). 4007605
Hay RJ, Clayton YM, Griffiths WA, Dowd PM. A comparative double blind study of ketoconazole and griseofulvin in dermatophytosis. Br J Dermatol 1985; 112: 691-6. (Controlled trial of ketoconazole vs griseofulvin for up to one year in 74 patients with dermatophytoses; similar efficacy; side effects were mild and there was no evidence of liver toxicity in either group “as assessed clinically or by liver function tests”). 3890924
Tabor E. Potential toxicity of ketoconazole. J Infect Dis 1985; 152: 233. (Letter stressing the importance of hepatotoxicity of ketoconazole). 4008991
Caballería Rovira E, Massó Ubeda RM, Aragó López JV, Sanchis Closa A. [Ketoconazole hepatotoxicity. Apropos of a case]. Med Clin (Barc) 1986; 86: 303-4. (73 year old developed jaundice 7 days after starting ketoconazole [bilirubin 4.4 mg/dL, ALT 302 U/L, Alk P 1633 U/L, 13% eosinophils], resolving clinically in 2 weeks, biochemically in 6 weeks). 3713348
Krivoy N, Bassan L. [Ketoconazole-induced acute liver necrosis]. Harefuah 1986; 110: 346-7. (63 year old woman developed jaundice 6 months after starting ketoconazole and continued therapy for 2 more weeks when she presented with confusion [bilirubin 27 mg/dL, ALT 935 U/L, Alk P 139 U/L, protime 15%], progressive coma and death in 3 days; autopsy showed massive necrosis). 3732948
Navarro Villena M. [Ketoconazole hepatotoxicity]. Med Clin (Barc) 1986; 87: 694. (40 year old woman developed rise in ALT to 300 U/L 7 days after starting ketoconazole with resolution within 30 days later, no symptoms or jaundice). 3796103
Leal-Cerro A, García-Luna PP, Jiménez Mejías E, Astorga R. [Hepatotoxicity of ketoconazole in patients with adrenal pathology]. Med Clin (Barc) 1987; 88: 519. Spanish. (Report of serial serum enzyme results from 4 patients treated with ketoconazole who had ALT elevations at 7 or 14 days, but all had normal values within a few weeks, 3 even while continuing therapy: Case 1). 3586729
Stricker BH, Blok AP, Bronkhorst FB, Van Parys GE, Desmet VJ. Ketoconazole-associated hepatic injury. A clinicopathological study of 55 cases. J Hepatol 1986; 3: 399-406. (Analysis of 55 cases of ketoconazole hepatotoxicity reported in Netherlands; 84% women, eosinophilia in 10%, fever 6%, rash 2%; enzymes predominantly hepatocellular; none fatal). 3559147
Tabor E. Hepatotoxicity of ketoconazole in men and in patients under 50. N Engl J Med 1987; 316: 1606-7. (Letter summarizing the hepatotoxicity of ketoconazole based largely on analysis of Lewis et al. [1984]). 3587297
Domingo Ribas C, Martí Ripoll S, Raventós Vilaplana A, Cabezuelo Hernández MA. [Hepatic toxicity of ketoconazole]. Rev Clin Esp 1987; 181: 542. (58 year old woman developed fatigue and anorexia 2 months after starting ketoconazole for dermatomycosis [bilirubin not given, ALT 225U/L, Alk P 600 U/L], resolving in 10 weeks after stopping). 3448668
Lake-Bakaar G, Scheuer PJ, Sherlock S. Hepatic reactions associated with ketoconazole in the United Kingdom. Br Med J (Clin Res Ed). 1987; 294: 419-22. (Between 1981-1984, 75 cases of ketoconazole hepatotoxicity were reported in the UK, 70% in women, mean age 56 years, mean latency 54 days, both hepatocellular and cholestatic cases, 5 deaths). 3101906
McCance DR, Ritchie CM, Sheridan B, Atkinson AB. Acute hypoadrenalism and hepatotoxicity after treatment with ketoconazole. Lancet 1987; 1: 573. (A patient with Cushing syndrome developed adrenal insufficiency and serum ALT elevations [303 U/L] one week after starting ketoconazole, resolving with stopping). 2881126
Meiring PD, Whitelaw DA. Ketoconazole induced hepatitis. S Afr Med J 1987; 72: 577-8. (74 year old man developed jaundice one year after starting ketoconazole [bilirubin 5.8 mg/dL, ALT 39 U/L, Alk P 1687 U/L], resolving within 2 months of stopping). 3672282
van Parys G, Evenepoel C, van Damme B, Desmet VJ. Ketoconazole-induced hepatitis: a case with a definite cause-effect relationship. Liver 1987; 7: 27-30. (59 year old woman developed jaundice 6 months after starting ketoconazole [bilirubin 8.0 mg/dL, ALT 1475 U/L, Alk P 234 U/L], resolving within 7 weeks of stopping, but subsequent inadvertent rechallenge for 7 days led to jaundice 1 week later [bilirubin 2.6 mg/dL, ALT 503 U/L]). 2952860
Bensaude RJ, Furet Y, Autret E, Brottes H, Billard JL, Breteau M. [Cholestatic hepatitis caused by ketoconazole]. Ann Gastroenterol Hepatol(Paris) 1988; 24: 55-7. French. (62 year old woman developed abdominal pain and fever 3 days after starting ketoconazole [bilirubin normal, ALT 1.5 times ULN, Alk P 2.5 times ULN], resolving clinically within 2 and biochemically within 7 days of stopping). 3389721
Benson GD, Anderson PK, Combes B, Ishak KG. Prolonged jaundice following ketoconazole-induced hepatic injury. Dig Dis Sci 1988; 33: 240-6. (55 and 39 year old men developed prolonged jaundice 27 and 23 days after starting ketoconazole [bilirubin 3.6 rising to 27.0 and 3.6 rising to 19 mg/dL, peak ALT 640 and 304 U/L, Alk P 436 and 223 U/L], with worsening for 1-2 months and jaundice with pruritus persisting for 3-4 months after stopping). 3338372
Kendrey G, Kovács M. [Histopathologic observations on acute liver lesions in patients taking Nizoral (ketoconazole)]. Morphol Igazsagugyi Orv Sz 1988; 28: 292-7. Hungarian. 3185578
De Wit S, Weerts D, Goossens H, Clumeck N. Comparison of fluconazole and ketoconazole for oropharyngeal candidiasis. Lancet 1989; 1: 746-50. (Randomized trial of fluconazole vs ketoconazole in 37 patients with HIV infection and oropharyngeal candidiasis; ALT or AST elevations occurred in 1 of 18 [6%] on fluconazole vs 4 of 19 [21%] on ketoconazole; fluconazole also more effective). 2564563
Cabeza Lamban F, Simal Gil E, Mur Villacampa M, Guerrero Navarro L. [Hepatotoxicity caused by ketoconazole]. Rev Esp Enferm Apar Dig 1989; 76: 92. (5 year old boy with cutaneous candidiasis developed abnormal liver tests 6 months after starting ketoconazole [bilirubin 3.2 mg/dL, ALT 475 U/L, Alk P 559 U/L] resolving rapidly upon stopping). 2799042
Van Cauteren H, Lampo A, Vandenberghe J, Vanparys P, Coussement W, De Coster R, Marsboom R. Toxicological profile and safety evaluation of antifungal azole derivatives. Mycoses 1989; 32 Suppl 1: 60-6. 2561186
Lambert DR, Siegle RJ, Camisa C. Griseofulvin and ketoconazole in the treatment of dermatophyte infections. Int J Dermatol 1989; 28: 300-4. (Review of efficacy and safety of griseofulvin and ketoconazole for superficial mycoses; rate of hepatotoxicity from ketoconazole ranges from 1:10,000 to 1:15,000, and is more common among women and in persons over 40 years of age; authors recommend routine monitoring of liver enzymes; in contrast, griseofulvin is “remarkably safe” and no deaths have been attributed directly to the drug). 2666321
Vilela MP, Ferraz ML, Franco DR. [Toxic hepatitis caused by ketoconazole: a report of 4 cases]. Rev Paul Med 1989; 107: 57-8. Portuguese. (Four women developed symptomatic hepatotoxicity 2-4 months after starting ketoconazole, [bilirubin 1.0, 2.1, 8.9 and 9.1 mg/dL, ALT 180-1500 U/L, Alk P 218-360 U/L], resolving within 2-3 months of stopping). 2616978
Gradon JD, Sepkowitz DV. Massive hepatic enlargement with fatty change associated with ketoconazole. DICP 1990; 24: 1175-6. (37 year old woman with AIDS developed hepatomegaly 11 months after starting ketoconzaole [bilirubin not mentioned, ALT 116 U/L, Alk P 180 U/L], liver biopsy showing fatty liver; also on zidovudine, a more likely candidate to cause this pattern of liver injury). 2089825
Ritchie D. Comment: consideration of amphotericin B hepatotoxicity. DCIP 1991; 25: 559-60. (Agrees that the case described by Gradon et al. was likely due to ketoconazole, but stresses that amphotericin B can also cause liver injury). 2068844
Brusko C, Marten J. Ketoconazole hepatotoxicity in a patient treated for environmental illness and systemic candidiasis. DCIP 1991; 25: 1321-5. (39 year old woman developed abnormal liver tests [ALT 367] one month after starting ketoconazole for chronic fatigue syndrome and candida with worsening over the next 6 months [bilirubin rising to 43 mg/dL, ALT 838 U/L, Alk P 186 U/L]; despite prompt discontinuation of ketoconazole, ultimately evolving into hepatic failure). 1815425
Knight T, Shikuma C, Knight J. Ketoconazole-induced fulminant hepatitis necessitating liver transplantation. J Am Acad Dermatol 1991; 25: 398-400. (A 39 year old woman developed elevated ALT levels 2 months after starting ketoconazole and, despite stopping, had progressive liver injury resulting in hepatic failure and death, [bilirubin 0.4 rising to 43 mg/dL, ALT 367 rising to 1170 U/L]: Case 4). 1832694
Simon DL. Comment: ketoconazole hepatotoxicity. Ann Pharmacother 1992; 26: 564-5. (Comment on case reported by Knight et al. [1991] suggesting that chronic acetaminophen ingestion may have caused the persistent injury). 1576399
Klausner MA. Ketoconazole and hepatitis. J Am Acad Dermatol 1992; 26: 1028-30. (Response by Janssen to review articles on ketaconazole, stressing the importance of hepatotoxicity and need to monitor liver tests during therapy). 1535078
Hay RJ. Risk/benefit ratio of modern antifungal therapy: focus on hepatic reactions. J Am Acad Dermatol 1993; 29: S50-4. (Review article on hepatotoxicity of antifungal agents, griseofulvin, ketoconazole, fluconazole, itraconazole and terbinafine; does not recommend routine monitoring, but stresses need to discontinue agent for hepatic injury with symptoms). 8315062
Gearhart M. Worsening of liver function with fluconazole and review of azole antifungal hepatotoxicity. Ann Pharmacother 1994; 28: 1177-81. (50 year old woman with probable chronic hepatitis C and cirrhosis had acute worsening of liver disease within a few days of starting fluconazole [bilirubin 1.6 rising to 6.6 mg/dL, AST rising from 66 to 1556 U/L, protime 19.2 rising to 29.8 sec], improving when fluconazole was stopped; discussion of azole antifungal agents and hepatotoxicity mentions that ketoconazole has been most frequently implicated in drug induced liver injury, perhaps because it is extensively metabolized by the liver). 7841574
Chien R, Yang L, Lin P, Liaw Y. Hepatic injury during ketoconazole therapy in patients with onchomycosis: a controlled cohort study. Hepatology 1997; 25: 103-7. (Controlled trial of ketaconazole vs griseofulvin in 211 patients with onchomycosis; ALT elevations occurred in 17.5% of ketaconazole vs none of griseofulvin recipients; 4 ketoconazole recipients developed symptoms after 28, 28, 35 and 63 days with ALT 254-963 U/L [median=490 U/L], minimal Alk P elevations [median=127 U/L] and jaundice in 3 patients; all recovered within 7 weeks ). 8985273
Bernuau J, Durand F, Pessayre D. Ketoconazole-induced hepatotoxicity. Hepatology 1997; 26: 802. (Letter disagreeing with the conclusions of Chien [1997] about role of monitoring ALT and speed of reversibility of hepatotoxicity). 9303518
Findor JA, Sorda JA, Igartua EB, Avagnina A. Ketoconazole-induced liver damage. Medicina 1998; 58: 277-81. (Five cases, 2 fatal, of ketoconazole related liver damage; in the 2 fatal cases there was a delay in stopping ketaconazole). 9713096
Van Puijenbroek EP, Metselaar HJ, Berghuis PH, Zondervan PE, Stricker BH. [Acute hepatocytic necrosis during ketoconazole therapy for treatment of onchomycosis. National Foundation for Registry and Evaluation of Adverse Effects]. Ned Tijdschr Geneeskd 1998; 142: 2416-8. Dutch. (Between 1986 and 1998, 18 cases of severe liver injury due to ketoconazole were reported to a Dutch National Registry including 3 men and 15 women, ages 21 to 65 years, latency 1 to 16 weeks, one third with fever, rash or eosinophilia, 69% with hepatocellular injury, 31% cholestatic-mixed; 15 with jaundice, 1 liver transplant and 1 death). 9864540
Bok RA, Small EJ. The treatment of advanced prostate cancer with ketoconazole: safety issues. Drug Saf 1999; 20: 451-8. (Ketaconazole inhibits synthesis of androgenic steroids by both testes and adrenals and has been used in higher doses [400 mg three times daily] to treat prostate cancer; side effects include liver test abnormalities in 4-20% and fulminant hepatitis in 0.01-0.1%; in studies in prostate cancer, hepatotoxicity occurred in 4.2%, mostly ALT and Alk P elevations that resolve with discontinuation). 10348095
García Rodriguez L, Duque A, Castellsague J, Pérez-Gutthann S, Stricker B. A cohort study on the risk of acute liver injury among users of ketoconazole and other antifungal drugs. Br J Clin Pharmacol 1999; 48: 847-52. (Population based study identified 5 cases of acute liver injury during antifungal therapy in 69,830 patients; relative risk for ketoconazole was 228 [~2:1,000 patients], itraconazole 17.7 [~1:10,000] and terbinafine 4.2 [~.2:10,000]). 10594489
Chien RN, Sheen IS, Liaw YF. Unintentional rechallenge resulting in a causative relationship between ketoconazole and acute liver injury. Int J Clin Pract 2003; 57: 829-30. (50 year old developed fatigue 2 months after starting ketoconazole [bilirubin 6.0 rising to 19.9 mg/dL, ALT 1326 U/L, Alk P 165 U/L, prothrombin time 13.3 seconds], resolving spontaneously starting 4 days after stopping; recurrence after 2 days of reexposure [bilirubin 4.9 mg/dL, ALT 1375 U/L, eosinophils 2%]). 14686574
Kim TH, Kim BH, Kim YW, Yang DM, Han YS, Dong SH, Kim HJ, et al. Liver cirrhosis developed after ketoconazole-induced acute hepatic injury. J Gastroenterol Hepatol 2003; 18: 1426-9. (41 year old woman developed nausea and jaundice 5 months after starting ketoconazole [bilirubin 12.8 mg/dL, ALT 1318 U/L, Alk P 268 U/L], with persistent jaundice and appearance of ascites and varices 4 months later, cirrhosis on biopsy and mildly abnormal liver tests for several years: Case 3). 14675275
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 6 were attributed to ketoconazole and 1 to itraconazole). 15390328
Fischer MA, Winkelmayer WC, Rubin RH, Avorn J. The hepatotoxicity of antifungal medications in bone marrow transplant recipients. Clin Infect Dis 2005; 41: 301-7. (Among 587 patients undergoing bone marrow transplantation, 123 had evidence of liver injury after transplant; case control analysis found increased rate of liver injury associated with fluconazole and amphotericin; ketoconazole, itraconazole and voriconazole were infrequently used and could not be evaluated). 16007524
Wingard J, Leather H. Hepatotoxicity associated with antifungal therapy after bone marrow transplantation. Clin Infect Dis 2005; 41: 308-10. (Editorial in response to the article by Fisher et al. [2005]; discusses the difficulties of detection, diagnosis, attribution and management of liver test abnormalities after bone marrow transplantation). 16007525
Videla C, Vega J, Borja H. Hepatotoxicity associated with cyclosporine monitoring using C2 recommendations in adults renal recipients receiving ketoconazole. Transplant Proc 2005; 37: 1574-6. (The interaction of cyclosporine and ketoconazole may result in toxic cyclosporine levels and liver injury; 6 cases of hepatotoxicity, 3 with jaundice between 4-21 days after renal transplant; improved with lowering cyclosporine dose and patients tolerated re-introduction of ketoconazole). 15866677
Song J, Deresinski S. Hepatotoxicity of antifungal agents. Curr Opin Investig Drugs 2005; 6: 170-7. (Extensive review of hepatotoxicity from antifungals; liver toxicity is a well documented complication of ketoconazole, asymptomatic ALT elevations in 2-10% of patients and symptomatic hepatitis in 1:10,000 to 1:15,000, usually hepatocellular; among antifungal agents, ketoconazole has been the agent most frequently linked to acute liver injury). 15751740
Cruciani M, Mengoli C, Malena M, Bosco O, Serpelloni G, Grossi P. Antifungal prophylaxis in liver transplant patients: a systematic review and meta-analysis. Liver Transpl 2006; 12: 850-8. (Metaanalysis found 6 studies with total of 698 patients comparing fluconazole, itraconazole or amphotericin vs placebo for prevention of fungal infections after liver transplantation; side effects were more with prophylaxis but liver toxicity was not discussed). 16628697
Girois SB, Chapuis F, Decullier E, Revol BG. Adverse effects of antifungal therapies in invasive fungal infections: review and meta-analysis. Eur J Clin Microbiol Infect Dis 2006; 25: 138-49. (Systematic review of adverse effects of antifungal therapy in 54 studies with 9228 patients; hepatotoxicity reported in 14.1-18.6% on amphotericin, 1.9% on fluconazole and 31.6% on itraconazole; but great variation in definitions and intensity of monitoring; ketoconazole not discussed). 16622909
Stein CA, Goel S, Ghavamian R. Hepatitis and rhabdomyolysis in a patient with hormone refractory prostate cancer on ketoconazole and concurrent lovastatin therapy. Invest New Drugs 2007; 25: 277-8. (84 year old man on long term lovastatin therapy developed fatigue and dark urine 4 weeks after starting ketoconazole for refractory prostate cancer [bilirubin and Alk P normal, ALT 829 U/L, CPK 47,250 U/L and myoglobin in the urine], resolving 3 weeks after stopping; suggested that ketoconazole caused increase in lovastatin to toxic levels becauseof inhibition of CYP 3A4 activity). 17216557
Lin C, Hu J, Yang S, Shin C, Huang S. Unexpected emergence of acute hepatic injury in patients treated repeatedly with ketoconazole. J Clin Gastroenterol 2008; 42: 432-3. (3 cases of severe hepatitis in patients who took multiple courses of ketoconazole, usually within 1-3 days of restarting with mild eosinophilia but no rash or fever; few specific details given). 18277890
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, two cases were attributed to fluconazole, and one to ketoconazole, one to itraconazole, none to voriconazole). 18955056
Antifungal drugs. Treat Guidel Med Lett 2009; 7: 95-102. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; ketoconazole is seldom used; other azoles have fewer side effects and are preferred; ketoconazole can cause hepatic toxicity and some cases are fatal) . 19940816
Wang JL, Chang CH, Young-Xu Y, Chan KA. Systematic review and meta-analysis of the tolerability and hepatotoxicity of antifungals in empirical and definitive therapy for invasive fungal infection. Antimicrob Agents Chemother 2010; 54: 2409-19. (Systematic review of 39 controlled trials in more than 8000 patients, found liver enzyme elevations in 14.5% of patients on amphotericin (pooled estimate); 19.7% on voriconazole; 18.9% itraconazole; 10% fluconazole; 2.8% anidulafungin; 7.2% caspofungin; and 5.7% micafungin; ketoconazole not discussed). 20308378
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 6 to antifungal agents, including 2 to ketoconazole). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, voriconazole ranked 21st with 52 cases [odds ratio 10.7] and fluconazole 30th with 42 cases [odds ratio 8.6]; no other antifungal agent listed in the top 41 causes). 21039766
Antifungal drugs. Treat Guidel Med Lett 2012;10: 61-8. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; side effects of ketoconazole include blurred vision, photophobia, fever, nausea, rash, photosensitivity, Stevens-Johnson syndrome, periostitis, confusion, anaphylactoid infusion reactions, and increased "transaminase levels"). 22825657
Yan JY, Nie XL, Tao QM, Zhan SY, Zhang YD. Ketoconazole associated hepatotoxicity: a systematic review and meta- analysis. Biomed Environ Sci 2013; 26: 605-10. (Analysis of 2404 publications on liver test abnormalities in patients receiving ketoconazole found an overall rate of 3.6-4.3% with no clear cut relation to total daily dose or indication, but lower rates in children [1.4%]). 23895707
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to ketaconazole or other antifungal agents). 23419359
Castinetti F, Guignat L, Giraud P, Muller M, Kamenicky P, Drui D, Caron P, et al. Ketoconazole in Cushing's disease: is it worth a try? J Clin Endocrinol Metab 2014; 99: 1623-30. (Retrospective analysis of 200 patients with Cushing disease treated with ketoconazole found liver enzyme elevations above 5 times ULN in 16%, but elevations resolved in all patients with dose reduction [50%] or stopping therapy [50%], and there were no deaths from acute liver failure). 24471573
Kao WY, Su CW, Huang YS, Chou YC, Chen YC, Chung WH, Hou MC, et al. Risk of oral anti-fungal agent-induced liver injury in Taiwanese. Br J Clin Pharmacol 2014; 77: 180-9. (Analysis of Taiwan National Health Insurance database from 2002-2008 identified 52 patients with drug induced liver injury among 90,847 users of oral antifungal agents, 28 of which [54%] were attributed to ketoconazole [4.9 per 10,000 persons], the rate increasing with increasing duration of therapy). 23750489
Greenblatt HK, Greenblatt DJ. Liver injury associated with ketoconazole: review of the published evidence. J Clin Pharmacol 2014; 54: 1321-9. (Review of the literature on hepatotoxicity of ketoconazole and alternatives to its use as an antifungal agent and as a tool in pharmacokinetic studies based upon its inhibition of CYP 3A4). 25216238
Raschi E, Poluzzi E, Koci A, Caraceni P, Ponti FD. Assessing liver injury associated with antimycotics: Concise literature review and clues from data mining of the FAERS database. World J Hepatol 2014; 6: 601-12. (Analysis of the FDA database on adverse reactions [2004 to 2011] identified 68,115 reports of liver injury including 1964 due to antifungal agents, the most common being terbinafine [422], fluconazole [412], voriconazole [361], amphotericin B [265], itraconazole [182], ketaconazole [94], and posaconazole [70]; among 112 cases with acute liver failure, causes included fluconazole [31], terbinafine [27], voriconazole [19], and ketoconazole [6]). 25232453
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 cases [1.6%] were attributed to antifungal agents including 6 triazoles [3 with jaundice and 2 hospitalized, no deaths], 4 due to fluconazole, 1 ketoconazole and 1 voriconazole). 25754159
Gupta AK, Daigle D, Foley KA. Drug safety assessment of oral formulations of ketoconazole. Expert Opin Drug Saf 2015; 14: 325-34. (Review of literature and regulatory actions regarding ketoconazole hepatotoxicity; mentions that oral ketoconazole was withdrawal from the market in Europe and Australia in 2013 and was subjected to more strigent safety warnings and more limited written indications in the US and Canada). 5409549
Lo Re V 3rd, Carbonari DM, Lewis JD, Forde KA, Goldberg DS, Reddy KR, Haynes K, et al. Oral azole antifungal medications and risk of acute liver injury, overall and by chronic liver disease status. Am J Med 2016; 129: 283-91. (Among 14,296 persons treated with oral ketoconazole analyzed from a Kaiser Permanente clinical database, the incidence of ALT or AST elevations above 200 U/L was 1.9% and severe acute liver injury 0.3%; one patient developed acute liver failure and required liver transplantation). 26597673
Kyriakidis I, Tragiannidis A, Munchen S, Groll AH. Clinical hepatotoxicity associated with antifungal agents. Expert Opin Drug Saf 2017; 16: 149-65. (Review of the hepatotoxicity of antifungal agents states that all antifungal agents may cause hepatic toxicity and discusses fluconazole, itraconazole, voriconazole, posaconazole and isavuconazole, but not ketoconazole). 27927037

## OTHER REFERENCE LINKS

1. Recent References on Ketoconazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ketoconazole)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ketoconazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=ketoconazole)